# Bortezomib

## OVERVIEW

### Introduction

Bortezomib is a small molecule proteasome inhibitor and antineoplastic agent that is used in treatment of multiple myeloma and mantle cell lymphoma. Bortezomib is associated with a moderate rate of serum enzyme elevations during treatment and with rare instances of clinically apparent, acute liver injury.

### Background

Bortezomib (bor tez’ oh mib) is a small molecule inhibitor of the 26S proteasome, the intracellular complex that degrades proteins involved in cell signaling and cell cycle regulation. Blocking proteasome activity prevents activation of factors involved in cell growth and resistance to chemotherapy induced apoptosis leading to cancer cell death. Preclinical studies in vitro and in vivo suggested that bortezomib had activity against several hematologic malignancies. Clinical trials of bortezomib in patients with multiple myeloma showed improvements in progression free survival. Bortezomib received approval for use in the United States in 2003 for therapy of multiple myeloma and mantle cell lymphoma when given in combination with other chemotherapeutic agents and has since become a component of initial as well as later regimens for myeloma. It is also widely used off label to treat immunoglobulin light chain amyloidosis. Bortezomib is available in powdered form in vials of 3.5 mg generically and under the brand name Velcade, and in solution in single use vials of 3.5 mg/1.4 mL under the brand name Boruzu. The usual adult dose is 1.3 mg/m^2^ given intravenously or subcutaneously in cycles of 4 doses over 28 days, usually in combination with other agents such as melphalan, cyclophosphamide, dexamethasone, and lenalidomide. Common side effects include nausea, diarrhea, constipation, anorexia, fatigue, thrombocytopenia, neutropenia, anemia, peripheral neuropathy, rash and fever. Uncommon, but potentially severe side effects include severe peripheral neuropathy, hypotension, cardiac and pulmonary toxicity, posterior reversible encephalopathy syndrome, thrombotic microangiopathy, bone marrow suppression and tumor lysis syndrome.

### Hepatotoxicity

In large clinical trials of bortezomib, elevations in serum aminotransferase levels were common, occurring in ~10% of patients. However, values greater than 5 times the upper limit of normal (ULN) were rare, occurring in less than 1% of recipients. Cases of clinically apparent liver injury including acute liver failure have been reported in patients receiving bortezomib; however, in many instances multiple concomitant medications were being taken and the specific role of bortezomib in causing the liver injury was not always clear. The onset of injury was typically within 1-2 weeks during the first cycle of therapy and usually, but not always recurred with retreatment. Cases characterized by acute hepatic necrosis and others by cholestatic hepatitis have been published, some of which were fatal. Hepatotoxicity is listed as a warning in the product label for bortezomib, and monitoring of liver tests during treatment is recommended.

Bortezomib has been linked to cases of reactivation of hepatitis B in susceptible patients who have HBsAg or antibody to hepatitis B core antigen (anti-HBc) without HBsAg in serum. Bortezomib is typically given with other agents including melphalan, cyclophosphamide, dexamethasone, lenalidomide and daratumumab, most of which can cause reactivation of hepatitis B on their own. Furthermore, hematopoietic stem cell transplantation is a common part of therapy of refractory multiple myeloma and is a well-known and common cause of reactivation of hepatitis B in susceptible patients. Several instances of reactivation have been described in patients receiving bortezomib containing regimens, arising after 4 to 18 months of therapy and presenting with a hepatocellular pattern of injury and high levels of HBV DNA. The mortality rate of hepatitis B reactivation is as high as 10% and fatal cases attributed to bortezomib have been described. Most cases of reactivation occur in patients with pre-existing HBsAg in serum who have not received antiviral prophylaxis against reactivation, however cases attributed to bortezomib have also been described in patients with anti-HBc without HBsAg. Because bortezomib is almost always given in combination with other agents that can cause reactivation, its independent contribution to the risk of reactivation is often uncertain. Nevertheless, cases of reactivation have occurred in patients treated with bortezomib alone.

Likelihood score: C (probable cause of clinically apparent drug induced liver injury as well as reactivation of hepatitis B).

### Mechanism of Injury

The mechanisms of liver injury accounting for serum enzyme elevations and hepatic toxicity during bortezomib therapy are not known. Bortezomib is metabolized in the liver, largely through the CYP 3A4 and 2C19 pathways, and liver injury may be related to production of a toxic or immunogenic intermediate. Bortezomib is susceptible to drug-drug interactions with agents that inhibit or induce these enzymes. Plasma levels of bortezomib are higher in patients with moderate or severe liver impairment, but not in those with mild impairment or with renal failure.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Clinically apparent liver injury should prompt immediate interruption of bortezomib therapy. Cases of hepatic failure attributed to bortezomib have been described, but not chronic hepatitis or vanishing bile duct syndrome. Patients who are to receive bortezomib should be screened for hepatitis B virus markers before starting therapy, and those with HBsAg in serum being candidates for antiviral prophylaxis. There is little information on cross reactivity in risk for hepatic injury between bortezomib and other cancer chemotherapeutic agents, including the tyrosine kinase inhibitors and other proteasome inhibitors such as carfilzomib and ixazomib.

Drug Class: Antineoplastic Agents; Protein Kinase Inhibitors

Other Drugs in the Subclass: Carfilzomib, Ixazomib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bortezomib – Velcade®, Boruzu®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Bortezomib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bortezomib | 179324-69-7 | C19H25BN4O4 | SID: 135051251

## ANNOTATED BIBLIOGRAPHY

References updated: 22 August 2026

Abbreviations used: ULN, upper limit of normal; CYP, cytochrome P450; HBsAg, hepatitis B surface antigen; HBV, hepatitis B virus; Anti-HBc, antibody to hepatitis B core antigen; Anti-HBs, antibody to HBsAg; HBeAg, hepatitis B e antigen; LDH, lactate dehydrogenase; CHOP, cyclophosphamide, doxorubicin, vincristine and prednisone; FAERS, FDA Adverse Event Reporting System.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of proteasome inhibitors such as bortezomib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published; bortezomib is listed as being implicated in causing hepatocellular injury).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=1521d321-e724-4ffc-adad-34bf4f44fac7 (Product label for bortezomib [August 2025] carries a warning for hepatic toxicity, mentioning that cases of acute liver failure have been reported and monitoring of routine liver tests is recommended, directing that therapy be interrupted to assess reversibility and noting that there is limited information on the safety of rechallenge).
Richardson PG, Barlogie B, Berenson J, Singhal S, Jagannath S, Irwin D, Rajkumar SV, et al. A phase 2 study of bortezomib in relapsed, refractory myeloma. N Engl J Med. 2003;348:2609-2617. (Among 193 patients with refractory multiple myeloma treated with bortezomib in cycles for up to 24 weeks, a clinical response occurred in 35% of patients and common side effects were nausea, diarrhea, fatigue, thrombocytopenia, and neuropathy; no mention of ALT elevations or hepatotoxicity). 12826635
Bortezomib (Velcade) for multiple myeloma. Med Lett Drugs Ther. 2003;45(1161):57-58. (Concise review of mechanism of action, efficacy, safety, and cost of bortezomib shortly after its approval for use in the United States; does not mention hepatotoxicity or serum enzyme elevations). 12865865
Rosiñol L, Montoto S, Cibeira MT, Bladé J. Bortezomib-induced severe hepatitis in multiple myeloma: a case report. Arch Intern Med. 2005;165:464-465. (68 year old man with advanced refractory multiple myeloma developed septic shock on the 6th day of cycle 1 of therapy, with subsequent increase in liver enzymes [ALT 2865 U/L, LDH 6448 U/L] followed by rapid recovery, but recurrence with two subsequent cycles [peak bilirubin 2.8 mg/dL, ALT 2750 U/L, LDH 6129 U/L] and rapid recovery each time). 15738379
Richardson PG, Sonneveld P, Schuster MW, Irwin D, Stadtmauer EA, Facon T, Harousseau JL, et al.; Assessment of Proteasome Inhibition for Extending Remissions (APEX) Investigators. Bortezomib or high-dose dexamethasone for relapsed multiple myeloma. N Engl J Med. 2005;352:2487-2498. (Among 669 patients with refractory multiple myeloma treated with multiple cycles of bortezomib or dexamethasone, response rates and survival were greater with bortezomib; common side effects were diarrhea, nausea, fatigue, constipation, peripheral neuropathy and thrombocytopenia; no mention of hepatotoxicity or ALT elevations). 15958804
Beysel S, Yeğın ZA, Yağci M. Bortezomib-associated late hepatitis B reactivation in a case of multiple myeloma. Turk J Gastroenterol. 2010;21:197-8. (58 year old Turkish man with multiple myeloma and chronic hepatitis B [HBsAg and HBeAg positive, HBV DNA 350,000 copies/mL, ALT normal] received lamivudine prophylaxis during chemotherapy that included 8 cycles of bortezomib [during which HBV DNA was undetectable] and 18 months later was found to have HBV DNA in serum [20,000 copies/mL] which was interpreted as reactivation of hepatitis B but was more likely just development of lamivudine resistance). 20872342
Tanaka H, Sakuma I, Hashimoto S, Takeda Y, Sakai S, Takagi T, Shimura T, et al. Hepatitis B reactivation in a multiple myeloma patient with resolved hepatitis B infection during bortezomib therapy : case report. J Clin Exp Hematop. 2012;52:67-9. (72 year old Japanese man with multiple myeloma, who was seropositive for anti-HBs without HBsAg or anti-HBc, was monitored for HBV DNA during therapy with bortezomib and was found to be weakly positive on one occasion which lead to entecavir therapy and completion of chemotherapy without further evidence of HBV reactivation, the evidence for reactivation was unconvincing). 22706534
Cornelis T, Beckers EA, Driessen AL, van der Sande FM, Koek GH. Bortezomib-associated fatal liver failure in a haemodialysis patient with multiple myeloma. Clin Toxicol (Phila). 2012;50:444-445. (70 year old man with renal failure on hemodialysis and multiple myeloma developed jaundice ten days after the first dose of bortezomib and dexamethasone [bilirubin 8.0 mg/dL, ALT 114 U/L, Alk P 461 U/L], with progression to hepatic failure and death 2 months later). 22462599
Paudice N, Farsetti S, Caroti L, Bandini S, Ciuti G, Tempestini A, Perfetto F, et al. [Severe recurrent intrahepatic cholestasis in systemic AL amyloidosis without obvious liver involvement: unexplained hepatic toxicity or a case of misdiagnosed liver amyloidosis?]. G Ital Nefrol. 2012 Jan-Feb;29(1):92-97. Italian. PMID: 22388910 (50 year old woman with renal failure, multiple myeloma and amyloidosis developed jaundice 10 days after starting bortezomib and dexamethasone, which resolved despite continuing bortezomib, but recurred after stopping and was suspected to be due to amyloidosis).
Kim GP, Mahoney MR, Szydlo D, Mok TS, Marshke R, Holen K, Picus J, et al. An international, multicenter phase II trial of bortezomib in patients with hepatocellular carcinoma. Invest New Drugs. 2012;30:387-394. (Among 35 patients with hepatocellular carcinoma treated with 1 to 12 cycles of bortezomib, the confirmed response rate was only 4% and toxicity was common; ALT elevations above 5 times ULN occurred in 2 patients and one died of hepatic failure). 20839030
LoRusso PM, Venkatakrishnan K, Ramanathan RK, Sarantopoulos J, Mulkerin D, Shibata SI, Hamilton A, et al. Pharmacokinetics and safety of bortezomib in patients with advanced malignancies and varying degrees of liver dysfunction: phase I NCI Organ Dysfunction Working Group study NCI-6432. Clin Cancer Res. 2012;18:2954-2963. (Among 61 patients with advanced cancer and varying degrees of liver dysfunction treated with bortezomib, mild impairment did not alter dose-normalized drug exposure while moderate or severe impairment raised it by roughly 60%, so that the dose could be escalated to 1.3 mg/m2 with mild but only to 1.0 mg/m2 with moderate or severe impairment; bilirubin and AST elevations were more frequent in the impaired groups but were attributed to the underlying liver disease rather than to bortezomib, 4 patients stopping therapy for rising bilirubin). 22394984
Goldberg R, Smith E, Bell S, Thompson A, Desmond PV. Bortezomib monotherapy in patients with multiple myeloma is associated with reactivation of hepatitis B. Intern Med J. 2013;43:835-6. (72 year old man with multiple myeloma and anti-HBc without HBsAg in serum developed an acute fulminant hepatitis 5 months after starting bortezomib [bilirubin 8.1 mg/dL, ALT 1,347 U/L, INR 3.1, HBsAg and HBeAg positive, HBV DNA > 108 IU/mL] with progressive hepatic failure and death despite entecavir treatment). 23841765
Hussain S, Jhaj R, Ahsan S, Ahsan M, Bloom RE, Jafri SM. Bortezomib induced hepatitis B reactivation. Case Rep Med. 2014;2014:964082. (73 year old woman with multiple myeloma, renal failure, and anti-HBc and anti-HBs without HBsAg in serum was treated with bortezomib and after 8 cycles was found to be HBsAg positive with high levels of HBV DNA [1.2x106 IU/mL] in serum which was treated with tenofovir but she died because of progressive myeloma several months later). 24876846
Laubach J, Hideshima T, Richardson P, Anderson K. Clinical translation in multiple myeloma: from bench to bedside. Semin Oncol. 2013;40:549-553. (Review of recent development of new agents to treat multiple myeloma, including bortezomib which showed activity against myeloma cell lines and was then evaluated clinically). 24135399
Wang H, Guan F, Chen D, Dou QP, Yang H. An analysis of the safety profile of proteasome inhibitors for treating various cancers. Expert Opin Drug Saf. 2014;13:1043-1054. (Review of efficacy and safety of bortezomib and several second generation proteasome inhibitors including carfilzomib, marizomib, ixazomib and oprozomib; no discussion of hepatotoxicity or serum enzyme elevations). 25005844
Till BG, Li H, Bernstein SH, Fisher RI, Burack WR, Rimsza LM, Floyd JD, DaSilva MA, et al. Phase II trial of R-CHOP plus bortezomib induction therapy followed by bortezomib maintenance for newly diagnosed mantle cell lymphoma: SWOG S0601. Br J Haematol. 2016;172:208-218. (Among 65 patients with mantle cell lymphoma treated with 6 cycles of CHOP with bortezomib followed by bortezomib maintenance, during which adverse events included neuropathy in 72% of patients; no mention of ALT elevations or hepatotoxicity). 26492567
Lu J, Chen WM, Geng CY, Durie BG, Huang XJ. Efficacy and safety of bortezomib in multiple myeloma patients with hepatitis B: a multicenter retrospective study. Chin Med J (Engl). 2016;129:274-278. (Retrospective review of outcome of bortezomib therapy in 25 HBsAg-positive patients with multiple myeloma [20 treated with nucleoside analogues for HBV] found no evidence of reactivation, ALT and HBV DNA levels remaining normal or negative). 26831227
Jain A, Malhotra P, Suri V, Varma S, Das A, Mitra S. Cholestasis in a patient of multiple myeloma: a rare occurrence of bortezomib induced liver injury. Indian J Hematol Blood Transfus. 2016;32(Suppl 1):181-183. (A 54 year old man with multiple myeloma developed jaundice a few days into a second 4-week cycle of cyclophosphamide, dexamethasone and bortezomib [bilirubin 15.5 mg/dL, ALT 367 U/L, Alk P 2456 U/L], recovering in 4 weeks and later tolerating cyclophosphamide and thalidomide). 27408386
Almaghrabi MM, Fortinsky KJ, Wong D. Severe acute hepatitis B in HBV-vaccinated partner of a patient with multiple myeloma treated with cyclophosphamide, bortezomib, and dexamethasone and autologous stem cell transplant. Case Reports Hepatol. 2017;2017:2463953. (68 year old man with multiple myeloma and anti-HBc and anti-HBs without HBsAg in serum received 5 cycles of bortezomib, cyclophosphamide, and dexamethasone and 4 months later underwent autologous hematopoietic stem cell transplant and 6 months later was found to have HBV reactivation with HBsAg and high levels of HBV DNA having also transmitted acute hepatitis B to his wife). 28428898
Tan C, Abdul-Majeed S, Cael B, Barta SK. Clinical pharmacokinetics and pharmacodynamics of bortezomib. Clin Pharmacokinet. 2019;58:157-168. (Review of the clinical pharmacology of bortezomib, which is metabolized largely by CYP 3A4 and 2C19, has equivalent systemic exposure whether given subcutaneously or intravenously, and reaches higher plasma levels in patients with moderate or severe liver impairment, for whom a lower starting dose is recommended, but not in those with renal impairment). 29802543
Ataca Atilla P, Yalçıner M, Atilla E, İdilman R, Beksaç M. Hepatitis B reactivation rate and fate among multiple myeloma patients receiving regimens containing lenalidomide and/or bortezomib. Turk J Hematol. 2019;36:266-273. (Among 178 patients with multiple myeloma, hepatitis B reactivation arose in 6 [3%] treated with bortezomib and in 8 [8%] treated with bortezomib and lenalidomide, and was more frequent in those with HBsAg than with anti-HBc without HBsAg and arose despite antiviral prophylaxis). 31368290
Talaat N, Tillmann HL. Injury pattern recognition to discriminate competing causes of liver injury. Liver Int. 2019;39:821-825. (68 year old woman with multiple myeloma and anti-HBc and anti-HBs without HBsAg in serum underwent multiple therapies including 2 hematopoietic stem cell transplants and was found to have reactivation of hepatitis B with HBsAg and high levels of HBV DNA in serum after a 3rd cycle of bortezomib). 30703293
Gertz MA, Dispenzieri A. Systemic amyloidosis recognition, prognosis, and therapy: a systematic review. JAMA. 2020;324:79-89. (Extensive review of the clinical features, pathogenesis, and management of amyloidosis, mentions that the combination of cyclophosphamide, bortezomib, and dexamethasone is the most frequently used regimen of immunoglobulin light chain amyloidosis in the United States, no discussion of adverse events or hepatotoxicity). 32633805
Kumar SK, Jacobus SJ, Cohen AD, Weiss M, Callander N, Singh AK, Parker TL, et al. Carfilzomib or bortezomib in combination with lenalidomide and dexamethasone for patients with newly diagnosed multiple myeloma without intention for immediate autologous stem-cell transplantation (ENDURANCE): a multicentre, open-label, phase 3, randomised, controlled trial. Lancet Oncol. 2020;21:1317-1330. (Among 1082 patients with multiple myeloma treated with bortezomib or carfilzomib combined with lenalidomide and dexamethasone, progression-free survival was similar [34.6 vs 34.4 months] but toxicity was less with bortezomib, no mention of ALT elevations but one patient receiving carfilzomib died of hepatic failure). 32866432
Kastritis E, Palladini G, Minnema MC, Wechalekar AD, Jaccard A, Lee HC, Sanchorawala V, et al; ANDROMEDA Trial Investigators. Daratumumab-based treatment for immunoglobulin light-chain amyloidosis. N Engl J Med. 2021;385:46-58. (Among 388 patients with immunoglobulin light chain amyloidosis treated with bortezomib, cyclophosphamide, and dexamethasone with or without daratumumab, hematologic complete responses were achieved in 53% vs 18% while serious adverse events were more frequent with the daratumumab regimen; no mention of ALT elevations or hepatotoxicity). 34192431
Dougherty JA, Elder CT. Managing multiple myeloma in the face of drug-induced adverse drug reaction. J Pharm Pract. 2022;35:500-504. (74 year old woman with newly diagnosed multiple myeloma developed sudden rise in serum aminotransferase levels 3 days after receiving a single subcutaneous injection of bortezomib [bilirubin 0.3 mg/dL, ALT 804 U/L, Alk P 174 U/L] with rapid fall into the normal range within the next ten days). 33317373
Sonneveld P, Dimopoulos MA, Boccadoro M, Quach H, Ho PJ, Beksac M, Hulin C, et al. Daratumumab, bortezomib, lenalidomide, and dexamethasone for multiple myeloma. N Engl J Med. 2024;390:301-313. (Among 709 patients with newly diagnosed multiple myeloma treated with bortezomib, lenalidomide and dexamethasone with or without daratumumab, progression free survival at 48 months was better with the four drug regimen [84% vs 68%], and the most common grade 3 or 4 adverse events in both groups were hematologic, neutropenia [62% vs 51%] and thrombocytopenia [29% vs 17%]; serum enzyme elevations and liver injury were not among the adverse events reported as common in either group). 38084760
Lv W, Li X, Xu J, Wang Y, Huang HY, Hu F, Cui Y, et al. Prognosis of hepatitis B virus reactivation in newly diagnosed multiple myeloma in modern era therapy: a retrospective study. PeerJ. 2024;12:e18475. (Among 355 patients with newly diagnosed multiple myeloma, 33 [9%] had reactivation of hepatitis B, the 2 year rate being higher with bortezomib containing than with other regimens [12% vs 3%], bortezomib being an independent risk factor along with HBsAg, and anti-HBc, and hematopoietic stem cell transplantation: HBV reactivation was accompanied by shorter overall and progression-free survival). 39498289
Huang J, Zhang M, Lin J, Yang X, Huang P, Zheng X. Safety assessment of proteasome inhibitors real world adverse event analysis from the FAERS database. Sci Rep. 2025;15:11628. (Analysis of adverse event reports for the proteasome inhibitors bortezomib, carfilzomib and ixazomib in the FDA’s Adverse Event Reporting System [FAERS] database found the strongest signals were for blood and lymphatic disorders with all 3 agents and for enteric neuropathy with bortezomib; hepatobiliary disorders were not among the leading signals for any of the three). 40185858
Lu C, Belmesk L, Bélisle A, Masse MS, Ouellette S, Cote B. Atypical presentation of DRESS/DiHS mimicking an acquired ichthyosis: A case report of bortezomib-induced severe erythroderma in multiple myeloma. SAGE Open Med Case Rep. 2026;14:2050313X251411500. PMID: 41602361 (46 year old Chinese woman with multiple myeloma developed severe erythroderma and DRESS syndrome after treatment with 5 cycles of bortezomib which responded to corticosteroids but relapsed repeatedly with worsening skin reactions on lowering the dose and was finally controlled on dupilumab [anti-IL-4RA]).
Kastritis E, Palladini G, Minnema MC, Wechalekar AD, Jaccard A, Lee HC, Sanchorawala V, et al.; ANDROMEDA Trial Investigators. Daratumumab-bortezomib-cyclophosphamide-dexamethasone for newly diagnosed amyloidosis: ANDROMEDA final survival analysis. Blood. 2026;148:1097-1107. (In the final follow up of the controlled trial of bortezomib, cyclophosphamide and dexamethasone with or without daratumumab for immunoglobulin light chain amyloidosis, 5 year survival was 76% vs 65%; no mention of hepatotoxicity or ALT elevations with therapy). 42118698
Lucijanić M, Orec J, Sorić E, Sabljić A, Jonjić Ž, Piršić M, Jaksic O. Hepatotoxicity profile of bortezomib-containing regimens for first-line multiple myeloma treatment. Pharmaceuticals (Basel). 2026;19:1205. (Among 115 patients with multiple myeloma treated with bortezomib-based regimens, liver test abnormalities were present in one third of patients before treatment and 23% developed new or worsening elevations during treatment, usually during the first month and usually cholestatic in pattern, values above 5 times ULN were uncommon [1% to 3%], and only one patient [1%] stopped therapy for liver test abnormalities). 42653701

## OTHER REFERENCE LINKS

1. Recent References on Bortezomib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bortezomib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Bortezomib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bortezomib)